# Gemcitabine

## OVERVIEW

### Introduction

Gemcitabine is a cytosine analogue and intravenously administered antineoplastic agent used in the therapy of several forms of advanced, pancreatic, lung, breast, ovarian and bladder cancer. Gemcitabine is associated with a high rate of transient serum enzyme elevations during therapy but is a very rare cause of acute, clinically apparent liver injury.

### Background

Gemcitabine (jem sye' ta been), 2^,^,2.-difluoro deoxycytidine, is a pyrimidine analogue that is widely used in solid tumor chemotherapy. Intracellularly, it is metabolized to diphosphate and triphosphate forms, both of which have antineoplastic activity inhibiting ribonucleotide reductase and competing with deoxycytidine triphosphate for incorporation into DNA. Gemcitabine is classified as an antimetabolite and is believed to act by inhibition of DNA synthesis in rapidly dividing cells. Gemcitabine was approved for use in cancer chemotherapy in the United States in 1996 and current indications include chemotherapy for advanced pancreatic, non-small cell lung, breast, ovarian and bladder cancers, either alone or in combination with other antineoplastic agents. Gemcitabine is administered intravenously and is available in vials of 10 and 50 mL in concentrations of 20 mg/mL generically and under the brand name Gemzar. The regimen of administration and dose vary by indication. A typical dosing regimen is 30 minute infusions of 1.0 to 1.2 g/m^2^ on days 1, 8 and 15 of each 28 day cycle of chemotherapy. Common side effects include bone marrow suppression, fatigue, diarrhea, nausea, gastrointestinal upset, rash, alopecia, and stomatitis.

### Hepatotoxicity

Elevations in serum aminotransferase levels occur in 30% to 90% of patients receiving cyclic therapy with gemcitabine. The elevations are generally mild-to-moderate, asymptomatic and self-limited, frequently resolving without discontinuation or even interruption of therapy. ALT or AST elevations above 5 times the upper limit of the normal range occur in 1-4% of patients yet rarely lead to symptoms or clinically apparent liver injury. Serum bilirubin and alkaline phosphatase elevations are less common, but also typically transient and mild. Despite wide use, gemcitabine has only rarely been implicated in rare cases of acute liver injury with jaundice, and most published cases have been reported in patients with underlying chronic liver disease or extensive hepatic metastases. The clinical features of hepatotoxicity from gemcitabine have not been well described. Most cases were marked by a progressive cholestasis and hepatic failure developing after several cycles of therapy in patients with preexisting chronic liver disease (hepatitis C, alcoholic liver disease) or significant hepatic metastases or local invasion.

As with many antineoplastic agents and regimens, therapy with gemcitabine has also been associated rare cases of with reactivation of hepatitis B in persons with preexisting HBsAg in serum. At least one case of sinusoidal obstruction syndrome (veno-occlusive disease) has been reported with use of gemcitabine in a patient with underlying chronic hepatitis C who received no other antineoplastic agent.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The frequent mild-to-moderate serum aminotransferase elevations that occur during gemcitabine therapy are likely due to direct hepatic toxicity. The clinically apparent liver injury linked to gemcitabine (cholestasis, HBV reactivation, sinusoidal obstruction syndrome) has occurred mostly in persons with underlying, preexisting liver disease. Whether this injury is idiosyncratic or the result of mild direct hepatotoxicity superimposed on significant underlying liver dysfunction is unknown.

### Outcome and Management

The severity of the liver injury linked to gemcitabine therapy is usually mild and self-limited, and dose modification or discontinuation is rarely necessary. However, the clinically apparent liver injury described with gemcitabine therapy tends to be severe and several fatal instances have been described. Virtually all of the clinically apparent liver injury related to gemcitabine has occurred in patients with underlying liver disease or extensive hepatic metastases or local invasion. In view of this, considerable care should be exercised in treating patients who have liver disease with gemcitabine. Furthermore, monitoring of routine liver tests before and during therapy is recommended with suspension of infusions if jaundice or clinically apparent liver injury arises. The possibility exists that the mild direct hepatotoxicity becomes clinically important in the presence of significant preexisting liver disease or dysfunction. The outcome of reexposure to gemcitabine after clinically apparent liver injury has not been reported. Also, there is no information on cross sensitivity to hepatic injury between gemcitabine and other antimetabolites or cytosine analogues such as cytarabine and capecitabine.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Pyrimidine Analogues: Azacitidine, Capecitabine, Cytarabine, Decitabine, Floxuridine, Fluorouracil, Trifluridine/Tipracil

## CASE REPORTS

### Case 1. Cholestatic liver injury arising during gemcitabine therapy.

[Modified from: Robinson K, Lambiase L, Li J, Monteiro C, Schiff M. Fatal cholestatic liver failure associated with gemcitabine therapy. Dig Dis Sci 2003; 48: 1804-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/14561005)]

A 45 year old woman with metastatic breast adenocarcinoma was treated with eight cycles of taxotere, cyclophosphamide and daunorubicin and achieved remission. Liver tests were repeatedly normal before, during and after therapy. Two years later, she presented with symptoms of pain, nausea, vomiting and dehydration and was found to have elevations in liver tests (bilirubin 0.8 mg/dL, ALT 222 U/L, alkaline phosphatase 202 U/L). Tests for hepatitis B and C were negative and there were no abnormalities or clear evidence of metastatic disease on computerized tomography of the abdomen and chest. She, nevertheless, was started on gemcitabine and carboplatin for presumed recurrence of breast cancer. She improved somewhat but continued to have fever and poor appetite. Chemotherapy was continued. Twelve days after a fourth dose of gemcitabine and carboplatin, she was found to be jaundiced (bilirubin 6.4 mg/dL) and chemotherapy was stopped. Over the next two weeks, she developed worsening symptoms and required hospital admission for management. She had muscle wasting, peripheral edema, abdominal protuberance and tenderness, hepatomegaly and signs of hepatic failure (confusion and asterixis). Serum bilirubin was 14.7 mg/dL and other liver tests remained abnormal (Table). Serum ammonia was 49 µmol/L (normal <35) and INR was 1.4. Repeat CT scans showed marked ascites, pleural effusions, but no evidence of hepatic metastases. A liver biopsy showed patchy lobular necrosis, steatosis and marked cholestasis which was interpreted as compatible with drug induced liver injury. Her hepatic failure worsened and she died 2 days later, 5 days after hospitalization and 3 weeks after stopping gemcitabine and carboplatin.

#### Key Points

Medication: | Gemcitabine (1300 mg intravenously once weekly)
Pattern: | Cholestatic (R=0.6)
Severity: | 5+ (fatal)
Latency: | Jaundice arising 5 weeks after initial dose
Recovery: | None
Other medications: | Carboplatin, morphine, oxycontin, anastrozole, methylprednisone, promethazine, esomeprazole, levofloxacin

#### Laboratory Values

Time After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | Pre | 222 | 202 | 0.8 | Admission
0 | | 60 | 160 | 0.6 | Albumin 2.7g/dL
Weekly infusions of gemcitabine and carboplatin started (x4)
5 days | | 158 | 257 | 1.0
34 days | 0 | 39 | 213 | 6.4 | Chemotherapy stopped
55 days | 21 days | 75 | 312 | 14.7 | Admission
56 days | 22 days | 86 | 307 | 14.2 | INR 1.4
57 days | 23 days | 69 | 271 | 12.1 | Liver biopsy
60 days | | Death from hepatic failure
Normal Values | | <42 | <128 | <1.2

#### Comment

A relatively young woman with a history of breast cancer developed progressive liver disease with marked cholestasis and hepatic synthetic dysfunction concurrent with starting a regimen of carboplatin and gemcitabine for presumed recurrent, metastatic disease. Attribution of the injury to gemcitabine is difficult, as she was on other medications that are known to cause liver injury including anastrozole and carboplatin, which are perhaps more likely causes of the injury. Nevertheless, gemcitabine has been linked to cholestatic liver injury with modest serum aminotransferase and alkaline phosphatase elevations in patients with underlying liver disease. This patient had evidence of hepatic dysfunction before gemcitabine was started, and it well might have exacerbated the underlying condition. The course and outcome is somewhat reminiscent of fatty liver with lactic acidosis and hepatic dysfunction, which occurs with many nucleoside analogues in susceptible patients.

### Case 2. Acute hepatocellular injury arising during gemcitabine therapy.

[Modified from: Saadati H, Peccerillo J, Kaley K, Schilsky ML, Saif MW. Gemcitabine-induced hepatitis in a pancreatic cancer patient receiving adjuvant therapy following metastasectomy. JOP 2009; 10: 573-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/19734642)]

A 68 year old man with adenocarcinoma of the pancreas underwent a Whipple procedure, followed by three 28 day cycles of gemcitabine. He was then found to have hepatic metastasis and switched to the combination of gemcitabine and oxaliplatin which was continued for a year, at which time repeat imaging studies showed resolution of the hepatic masses. He was followed on no therapy and had no evidence of recurrence until 3 years later when a lung mass was detected and found to be a metastasis on resection. He was restarted on 28 day cycles of gemcitabine which were well tolerated until cycle six, when serum enzymes were found to be elevated and gemcitabine was held. He subsequently developed mild jaundice [bilirubin 3.7 mg/dL, ALT 1660 U/L, alkaline phosphatase 226 U/L] and he was admitted for evaluation. Tests for acute hepatitis were said to be negative and magnetic resonance imaging of the liver showed fatty infiltration, but no evidence of biliary obstruction or recurrence of hepatic metastases. He remained mildly jaundiced for several days, but complained of no symptoms and recovered rapidly and completely. In follow up, liver tests were normal. Gemcitabine was not restarted.

#### Key Points

Medication: | Gemcitabine (six 28 day cycles; dose not given)
Pattern: | Hepatocellular (R=27)
Severity: | 3+ (jaundice, hospitalization)
Latency: | Approximately 5 months
Recovery: | Within 3 weeks
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Days After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
4 months | Pre | 20 | | 0.4
4.5 | Pre | 210 | 165 | 1.0
5 months | 0 | 1200 | 235 | 1.7
| 1 day | 1410 | 226 | 2.4
| 2 days | 1660 | 260 | 3.8
| 3 days | 1580 | 226 | 3.7
| 4 days | 1550 | 220 | 3.6
| 5 days | 1500 | 210 | 3.9
| 7 days | 950 | 210 | 2.8
| 16 days | 120 | 110 | 1.1
| 22 days | 20 | 70 | 0.6
Normal Values | | <25 | <130 | <1.2

* Several values estimated from Figure 1.

#### Comment

This patient with metastatic adenocarcinoma of the pancreas developed a mild, acute viral hepatitis-like syndrome after 5 cycles of gemcitabine. No other medications were mentioned. The report does not provide results of virologic and serological testing. Similar instances of acute hepatocellular injury with jaundice have not been reported with gemcitabine, and the possibility exists that the acute hepatitis was due to acute viral hepatitis (HEV or HCV are often difficult to diagnose in the acute setting).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Gemcitabine – Generic, Gemzar®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Gemcitabine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Gemcitabine | 95058-81-4 | C9-H11-F2-N3-O4 | Gemcitabine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 09 March 2018

Zimmerman HJ. Hepatic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999; gemcitabine is not mentioned).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of hepatotoxicity of anticancer agents; gemcitabine is listed as a frequent cause of mild to moderate aminotransferase elevations and linked to one case of acute liver failure).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Gemcitabine. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1700-1. (Textbook of pharmacology and therapeutics; gemcitabine is a cytidine derivative that has become an important drug for patients with metastatic pancreatic, non-small cell lung, ovarian and bladder cancers).
Anderson H, Lund B, Bach F, Thatcher N, Walling J, Hansen HH. Single-agent activity of weekly gemcitabine in advanced non-small-cell lung cancer: a phase II study. J Clin Oncol 1994; 12: 1821-6. (Among 79 patients with non-small-cell lung cancer treated with 368 courses of gemcitabine, 12% had ALT elevations above 5 times ULN, but all recovered without symptoms or jaundice). 8083706
Abratt RP, Bezwoda WR, Falkson G, Goedhals L, Hacking D, Rugg TA. Efficacy and safety profile of gemcitabine in non-small-cell lung cancer: a phase II study. J Clin Oncol 1994; 12: 1535-40. (Among 76 patients with non-small cell lung cancer given gemcitabine, 73% had ALT elevations which rose above 5 times ULN in 13%). 8040664
Tonato M, Mosconi AM, Martin C. Safety profile of gemcitabine. Anticancer Drugs 1995; 6 Suppl 6: 27-32. (Review of side effects of gemcitabine based upon results from 790 patients in pivotal studies; ALT elevations occurred in 68% of patients, but were above 5 times ULN in only 9.2% and the cause of discontinuation in only 0.5%). 8718422
Martin C, Lund B, Anderson H, Thatcher N. Gemcitabine: once-weekly schedule active and better tolerated than twice-weekly schedule. Anticancer Drugs 1996; 7: 351-7. (Comparison of once vs twice weekly gemcitabine from 18 studies in various cancers; ALT elevations above 5 times ULN occurred in 9.2% of patients with once weekly versus 21.2% with twice weekly gemcitabine, but only 4 patients had to stop therapy because of liver test abnormalities; one patient ["who had a long history of chronic alcoholism"] died of liver failure). 8792011
Carmichael J, Fink U, Russell RC, Spittle MF, Harris AL, Spiessi G, Blatter J. Phase II study of gemcitabine in patients with advanced pancreatic cancer. Br J Cancer 1996; 73: 101-5. (Among 34 patients with advanced pancreatic carcinoma treated with gemcitabine, ALT elevations occurred in 90% of patients, but were above 5 times ULN in only ~15% and all were "reversible"). 8554969
Kaufmann M, von Minckwitz G. Gemcitabine in ovarian cancer: an overview of safety and efficacy. Eur J Cancer 1997 Jan; 33 Suppl 1: S31-3. (Review of status of gemcitabine in ovarian carcinoma; no mention of hepatotoxicity). 9166098
Green MR. Gemcitabine safety overview. Semin Oncol 1996; 23(5 Suppl 10): 32-5. (Review of side effects of gemcitabine from 790 patients in 18 studies in various cancers; "mild transaminase increases were common but were rarely dose limiting"). 8893879
Cortes-Funes H, Martin C, Abratt R, Lund B. Safety profile of gemcitabine, a novel anticancer agent, in non-small cell lung cancer. Anticancer Drugs 1997; 8: 582-7. (Analysis of side effects of gemcitabine based upon results from 360 patients with non-small cell lung cancer; "transient asymptomatic and rapidly reversible" elevations of ALT occurred in 70% of patients and were above 5 times ULN in 12%). 9300572
Yokoyama A, Nakai Y, Yoneda S, Kurita Y, Niitani H. Activity of gemcitabine in the treatment of patients with non-small cell lung cancer: a multicenter phase II study. Anticancer Drugs 1997; 8: 574-81. (Among 67 patients with non-small cell lung cancer treated with 2 to 20 courses of gemcitabine, ALT or AST elevations occurred in 36% of patients; no mention of clinically apparent liver injury). 9300571
Zatloukal P, Kanitz E, Magyar P, Jassem J, Krzakowski M, Pawlicki M, Petruzelka L, et al. Gemcitabine in locally advanced and metastatic non-small cell lung cancer: the Central European phase II study. Lung Cancer 1998; 22: 243-50. (Among 80 patients with advanced non-small cell lung cancer treated with 1 to 9 cycles of gemcitabine, ALT elevations occurred in 28% but were above 5 times ULN in only 1.3%, and were not associated with clinically apparent liver injury). 10048477
Zinzani PL, Magagnoli M, Bendandi M, Orcioni GF, Gherlinzoni F, Albertini P, Pileri SA, et al. Therapy with gemcitabine in pretreated peripheral T-cell lymphoma patients. Ann Oncol 1998; 9: 1351-3. (Among 13 patients with lymphoma treated with gemcitabine, one had transient ALT elevations). 9932168
Lorusso V, Pollera CF, Antimi M, Luporini G, Gridelli C, Frassineti GL, Oliva C, et al. A phase II study of gemcitabine in patients with transitional cell carcinoma of the urinary tract previously treated with platinum. Italian Co-operative Group on Bladder Cancer. Eur J Cancer 1998; 34: 1208-12. (Among 35 patients with urinary tract carcinoma treated with gemcitabine, ALT or AST elevations above 5 times ULN occurred in 11%). 9849481
Aapro MS, Martin C, Hatty S. Gemcitabine.a safety review. Anticancer Drugs 1998; 9: 191-201. (Review of safety of gemcitabine based upon results from 22 studies in 979 patients with various cancers; 42% of courses were associated with ALT elevations, but they were usually mild and transient, being above 5 times ULN in only 9.6% and resulting in drug discontinuation in only 0.5% of patients). 9625429
Dobbie M, Hofer S, Oberholzer M, Herrmann R. Veno-occlusive disease of the liver induced by gemcitabine. Ann Oncol 1998; 9: 681. (48 year old woman with chronic hepatitis C and non-small cell lung cancer developed sinusoidal obstruction syndrome after 4 cycles of gemcitabine [bilirubin 5 times ULN, ALT 10 times ULN], with progressive liver failure and death within 8 days, autopsy showing sinusoidal obstruction). 9681086
Oettle H, Pelzer U, Hochmuth K, Diebold T, Langrehr J, Schmidt CA, Arning M, et al. Phase I trial of gemcitabine (Gemzar), 24 h infusion 5-fluorouracil and folinic acid in patients with inoperable pancreatic cancer. Anticancer Drugs 1999; 10: 699-704. (Among 16 patients with advanced pancreatic cancer treated with 5FU, folinic acid and gemcitabine, hepatotoxicity was dose limiting for 5FU and one patient treated with the highest dose died of hepatic failure). 10573201
Coeman DC, Verbeken EK, Nackaerts KL, Demedts MG, Vansteenkiste JF. A fatal case of cholestatic liver failure probably related to gemcitabine. Ann Oncol 2000; 11: 1503. (73 year old man with undifferentiated metastatic carcinoma developed progressive jaundice after the 6th 28 day cycle of gemcitabine, leading to multiorgan failure and death, autopsy showing bland centrolobular necrosis with cholestasis). 11142494
Savage DG, Rule SA, Tighe M, Garrett TJ, Oster MW, Lee RT, Ruiz J, et al. Gemcitabine for relapsed or resistant lymphoma. Ann Oncol 2000; 11: 595-7. (Study of 15 patients with relapsed or resistant lymphoma treated with gemcitabine makes no mention of ALT elevations or hepatotoxicity). 10907954
Samlowski WE, Gundacker H, Kuebler JP, Giguere JK, Mills GM, Schuller DE, Ensley JF. Evaluation of gemcitabine in patients with recurrent or metastatic squamous cell carcinoma of the head and neck: a Southwest Oncology Group phase II study. Invest New Drugs 2001; 19: 311-5. (Among 26 patients with advanced head and neck cancer, one died of liver failure after the initial infusion, thought to be due to progressively enlarging liver metastases). 11561690
Spielmann M, Llombart-Cussac A, Kalla S, Espié, Namer M, Ferrero JM, Diés V, et al. Single-agent gemcitabine is active in previously treated metastatic breast cancer. Oncology 2001; 60: 303-7. (Among 47 patients with metastatic breast cancer treated with gemcitabine, one patient with severe liver involvement at entry died of liver failure 5 days after the initial infusion; no other mention of ALT elevations or hepatotoxicity). 11408796
Blackstein M, Vogel CL, Ambinder R, Cowan J, Iglesias J, Melemed A. Gemcitabine as first-line therapy in patients with metastatic breast cancer: a phase II trial. Oncology 2002; 62: 2-8. (Among 34 patients with metastatic breast cancer treated with gemcitabine, 65% had ALT elevations which were above 5 times ULN in 12%). 11810037
Ikeda M, Okada S, Tokuuye K, Ueno H, Okusaka T. A phase I trial of weekly gemcitabine and concurrent radiotherapy in patients with locally advanced pancreatic cancer. Br J Cancer 2002; 86: 1551-4. (Among 15 patients with locally advanced pancreatic cancer given gemcitabine in increasing doses, ALT elevations above 5 times ULN occurred in 33% and required dose modification in 2 patients given the highest tolerated doses). 12085203
Cheong K, Li J, Karapetis CS. Gemcitabine and reactivation of hepatitis B. Med Oncol 2003; 20: 385-8. (70 year old woman with HBsAg and an undifferentiated carcinoma developed rise in HBV DNA [2,700 to 160,000 copies/mL] and ALT [41 to 255 U/L], without symptoms or jaundice after three 28 day cycles of gemcitabine [without other agents], values returning to baseline within 2 months of stopping). 14716036
Robinson K, Lambiase L, Li J, Monteiro C, Schiff M. Fatal cholestatic liver failure associated with gemcitabine therapy. Dig Dis Sci 2003; 48: 1804-8. (45 year old woman with breast cancer with liver metastases and ALT elevations developed jaundice soon after starting gemcitabine [bilirubin 6.4 rising to 14.7 mg/dL, ALT 222 U/L, Alk P 202 U/L], with hepatic failure and death; liver biopsy showing fat, cholestasis and patchy hepatocellular necrosis: Case 1). 14561005
Modi S, Seidman AD. Single-agent gemcitabine in the treatment of advanced breast cancer. Clin Breast Cancer 2004; 4 Suppl 3: S101-6. (Review of role of gemcitabine as a single agent in advanced breast cancer, summarizing 10 phase II trials; in one study, ALT elevations above 5 times ULN occurred in 18% of patients, but hepatotoxicity was not otherwise discussed). 14754466
Kosmidis PA, Kalofonos HP, Christodoulou C, Syrigos K, Makatsoris T, Skarlos D, Bakogiannis C, et al. Paclitaxel and gemcitabine versus carboplatin and gemcitabine in patients with advanced non-small-cell lung cancer. A phase III study of the Hellenic Cooperative Oncology Group. Ann Oncol 2008; 19: 115-22. (Among 452 patients with advanced non-small cell lung cancer randomized to receive gemcitabine with either paclitaxel or carboplatin, ALT or AST elevations above 5 times ULN occurred in 0.9% vs 1.2% of patients, but other toxicities were more common with the carboplatin than paclitaxel regimen). 17938425
Matsuda M, Watanabe G, Mine S, Hashimoto M. [Fatal liver failure associated with gemcitabine hydrochloride therapy]. Gan To Kagaku Ryoho 2008; 35: 157-9. Japanese. (79 year old man with chronic hepatitis C and pancreatic cancer developed jaundice after radiation therapy and the 6th cycle of gemcitabine [bilirubin 4.0 rising to 9.2 mg/dL, ALT 77 U/L, Alk P 560 U/L], with progression to liver failure and death; autopsy showing portal vein invasion by cancer and extensive centrolobular necrosis). 18195549
Saadati H, Peccerillo J, Kaley K, Schilsky ML, Saif MW. Gemcitabine-induced hepatitis in a pancreatic cancer patient receiving adjuvant therapy following metastasectomy. JOP 2009; 10: 573-5. (68 year old man with advanced, metastatic pancreatic cancer developed dark urine and liver test abnormalities 5 cycles of gemcitabine [bilirubin 3.7 mg/dL, ALT 1660 U/L, Alk P 226 U/L], resolving within 7 weeks of stopping: Case 2). 19734642
Tanaka H, Takamori H, Eto S, Ozaki N, Akaboshi S, Nakahara O, Ida S, et al. [Acute liver injury with hepatic encephalopathy associated with gemcitabine administration for adjuvant chemotherapy in an HBV carrier with pancreatic cancer]. Gan To Kagaku Ryoho 2010; 37: 1783-6. Japanese. (75 year old HBsAg positive woman with pancreatic cancer developed jaundice after a 6th weekly dose of gemcitabine [bilirubin 3.7 mg/dL, ALT 37 U/L, Alk P 471 U/L, INR 1.9, ammonia 72 rising to 300 µg/dL], without change in hepatitis B markers [HBV DNA undetectable], resolving within 4 weeks of stopping therapy). 20841947
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 2 attributed to antineoplastic agents, 1 to melphalan and 1 to gemtuzumab, but none gemcitabine or other antimetabolites). 20949552
García Del-Muro X, López-Pousa A, Maurel J, Martín J, Martínez-Trufero J, Casado A, Gómez-España A, et al.; Spanish Group for Research on Sarcomas. Randomized phase II study comparing gemcitabine plus dacarbazine versus dacarbazine alone in patients with previously treated soft tissue sarcoma: a Spanish Group for Research on Sarcomas study. J Clin Oncol 2011; 29: 2528-33. (Among 109 patients with soft tissue sarcoma treated with 386 cycles of dacarbazine with or without gemcitabine, overall survival was better with the combination; no mention of ALT elevations or hepatotoxicity). 21606430
Choi JG, Seo JH, Oh SC, Choi CW, Kim JS. A phase II trial of gemcitabine plus capecitabine for patients with advanced pancreatic cancer. Cancer Res Treat 2012; 44: 127-32. (Among 50 patients with advanced pancreatic cancer treated with the combination of gemcitabine and capecitabine, median overall survival was 10 months; no mention of ALT elevations or hepatotoxicity). 22802751
Ioka T, Katayama K, Tanaka S, Takakura R, Ashida R, Kobayashi N, Taniai H. Safety and effectiveness of gemcitabine in 855 patients with pancreatic cancer under Japanese clinical practice based on post-marketing surveillance in Japan. Jpn J Clin Oncol 2013; 43: 139-45. (Among 890 patients with advanced pancreatic cancer treated with gemcitabine and reported to a Japanese registry, hepatic adverse events were reported in 1.3% of patients, but none were graded as severe). 23275642
Joerger M, Huitema AD, Koeberle D, Rosing H, Beijnen JH, Hitz F, Cerny T, et al. Safety and pharmacology of gemcitabine and capecitabine in patients with advanced pancreatico-biliary cancer and hepatic dysfunction. Cancer Chemother Pharmacol 2014; 73: 113-24. (Among 12 patients with advanced pancreatic or biliary cancer and varying degrees of liver dysfunction, the toxicity of gemcitabine [largely hematologic] did not correlate with degree of liver dysfunction). 24166106
Yang ZY, Yuan JQ, Di MY, Zheng DY, Chen JZ, Ding H, Wu XY, et al. Gemcitabine plus erlotinib for advanced pancreatic cancer: a systematic review with meta-analysis. PLoS One 2013; 8: e57528. (Review of literature on efficacy and safety of the combination of erlotinib and gemcitabine for advanced pancreatic cancer; the addition of erlotinib was associated with a prolongation of survival by 0.3 months and the adverse event rate was high "but not surprising"; no mention of hepatotoxicity). 23472089
Fuchs CS, Azevedo S, Okusaka T, Van Laethem JL, Lipton LR, Riess H, Szczylik C, et al. A phase 3 randomized, double-blind, placebo-controlled trial of ganitumab or placebo in combination with gemcitabine as first-line therapy for metastatic adenocarcinoma of the pancreas: the GAMMA trial. Ann Oncol 2015; 26 :921-7. (Among 800 patients with metastatic pancreatic cancer treated with gemcitabine with or without ganitumab [monoclonal anti-IGF1R], overall survival was the same in all groups, and ALT elevations arose in 16% but were above 5 times ULN in less than 1%). 25609246
O'Neil BH, Scott AJ, Ma WW, Cohen SJ, Leichman L, Aisner DL, Menter AR, et al. A phase II/III randomized study to compare the efficacy and safety of rigosertib plus gemcitabine versus gemcitabine alone in patients with previously untreated metastatic pancreatic cancer. Ann Oncol 2015; 26: 1923-9. (Among 160 patients with metastatic pancreatic cancer treated with gemcitabine with or without rigosertib [a multikinase inhibitor], overall survival was the same in both groups and ALT elevations arose in 13% of patients and were above 5 times ULN in 1%). 26091808
Uesaka K, Boku N, Fukutomi A, Okamura Y, Konishi M, Matsumoto I, Kaneoka Y, et al.; JASPAC 01 Study Group. Adjuvant chemotherapy of S-1 versus gemcitabine for resected pancreatic cancer: a phase 3, open-label, randomised, non-inferiority trial (JASPAC 01). Lancet 2016; 388: 248-57. (Among 377 Japanese patients with pancreatic cancer given adjuvant chemotherapy with gemcitabine or "S-1", ALT elevations arose in 78% of patients and were above 5 times ULN in 4%). 27265347
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2025754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents, but none were linked to use of gemcitabine).
Schultheis B, Reuter D, Ebert MP, Siveke J, Kerkhoff A, Berdel WE, Hofheinz R, et al. Gemcitabine combined with the monoclonal antibody nimotuzumab is an active first-line regimen in KRAS wildtype patients with locally advanced or metastatic pancreatic cancer: a multicenter, randomized phase IIb study. Ann Oncol 2017; 28: 2429-35. (Among 192 patients with pancreatic cancer treated with gemcitabine with or without nimotuzumab [anti-EGFR], median overall survival was greater with the combination [8.6 vs 5.1 months] while adverse event rates were similar; ALT elevations and hepatotoxicity not mentioned). 28961832
Benson AB 3rd, Wainberg ZA, Hecht JR, Vyushkov D, Dong H, Bendell J, Kudrik F. A Phase II randomized, double-blind, placebo-controlled study of simtuzumab or placebo in combination with gemcitabine for the first-line treatment of pancreatic adenocarcinoma. Oncologist 2017; 22: 241-e15. (Among 240 patients with metastatic pancreatic cancer treated with gemcitabine with or without simtuzumab [monoclonal anti-LOXL1], overall survival was similar in both groups as were adverse event rates with ALT elevations in 89% and 82% of subjects). 28246206
Neoptolemos JP, Palmer DH, Ghaneh P, Psarelli EE, Valle JW, Halloran CM, Faluyi O, et al.; European Study Group for Pancreatic Cancer. Comparison of adjuvant gemcitabine and capecitabine with gemcitabine monotherapy in patients with resected pancreatic cancer (ESPAC-4): a multicentre, open-label, randomised, phase 3 trial. Lancet 2017; 389: 1011-24. (Among 730 patients with resected pancreatic cancer given adjuvant chemotherapy with gemicitabine with or without capecitabine, overall survival was 25.5 vs 28.0 months while adverse event rates were only slightly higher with the combination; no mention of ALT elevations or hepatotoxicity). 28129987

## OTHER REFERENCE LINKS

1. Recent References on Gemcitabine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Gemcitabine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Gemcitabine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Gemcitabine)